# Methenamine

## OVERVIEW

### Introduction

Methenamine is a urinary tract antiseptic that is used as suppressive therapy for chronic or recurrent urinary tract infections. Methenamine has not been linked to serum enzyme elevations or to instances of clinically apparent acute liver injury.

### Background

Methenamine (meth” en a mene’) also known as hexamethylenetetramine or urotropin is a heterocyclic molecule used as long term prophylaxis of recurrent urinary tract infections. Methenamine is rapidly absorbed and excreted in the urine where it decomposes at an acidic pH into formaldehyde and ammonia. Formaldehyde is directly bactericidal. Almost all bacteria are sensitive to formaldehyde and resistance to it does not develop. For these reasons, methenamine is particularly helpful in suppressing recurrent or chronic urinary tract infections. The breakdown of methenamine to formaldehyde in the bladder requires an acidic pH, for which reason it is usually given as a mandelic acid or hippurate salt or with agents that acidify the urine such as ammonium or vitamin C. Methenamine was approved for use in the United States in 1976 but is not widely used. The current indications are for prevention of frequently recurrent urinary tract infections. It is not considered effective in treating acute urinary infections. Methenamine is available generically as either a mandelate or hippuric salt in tablets of 1000 mg. The typical dose in adults is 1 gram twice daily (methenamine hippurate) to four times daily (methenamine mandelate). Methenamine can cause dysuria, urinary frequency, and hematuria particularly at high doses. Other uncommon side effects are nausea, anorexia, indigestion, abdominal discomfort and rash. Severe adverse events are rare but may include hypersensitivity reactions. Methenamine is contraindicated in patients with advanced liver disease because of the generation of ammonia.

### Hepatotoxicity

In prospective controlled trials, methenamine was generally well tolerated at conventional doses and no episodes of serum aminotransferase elevations or clinically apparent liver injury were reported. Since its approval and in over 100 years of general use, there have been no reports of clinically apparent liver injury attributable to methenamine. Thus, clinically apparent liver injury from methenamine must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why methenamine rarely causes liver injury is probably due to its lack of hepatic metabolism and rapid unchanged urinary excretion.

Drug Class: Antiinfective Agents, Urinary Tract Infection Agents

Other Drugs in the Subclass: Fosfomycin, Nitrofurantoin, Sulfamethoxazole-Trimethoprim

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methenamine hippurate – Generic, Hiprex®

Methenamine mandelate – Generic, Mandelamine®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methenamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methenamine | 100-97-0 | C6-H12-N4

## ANNOTATED BIBLIOGRAPHY

References updated: 22 January 2021

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HH. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 589-637. (Textbook of hepatotoxicity published in 1999; methenamine is not discussed).
Moseley RH. Nitrofurantoin. Hepatotoxicity of antimicrobial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 469-70. (Expert review of antibiotic induced liver injury does not discuss methenamine).
MacDougall C. Methenamine. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1018. (Textbook of pharmacology and therapeutics mentions that methenamine is a urinary antiseptic that generates formaldehyde in the bladder when urine pH is <6 and is helpful in treating chronic, recurrent urinary tract infections not having the problem of bacterial resistance).
(1968). Methenamine hippurate (Hiprex). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, and safety of methenamine hippurate shortly after its introduction into clinical practice, mentions that uncontrolled studies have shown that both the hippurate and mandelate methenamine improve symptoms and sterilize urine in patients with recurrent bacterial cystitis and that no serious adverse events have been reported with either).
Harding GK, Ronald AR. (1974). A controlled study of antimicrobial prophylaxis of recurrent urinary infection in women. N Engl J Med. (Among 40 women or girls with recurrent urinary tract infections treated in rotating 3 month courses of different antibiotic regimens or placebo, recurrent infections were lowest with trimethoprim-sulfamethoxazole [0.1], intermediate with sulfamethazole alone [1.6] or methenamine and ascorbic acid [1.6] and highest with placebo [3.2 per patient-year], and all regimens “were well tolerated” with no mention of ALT elevations or hepatoxicity).
Gleckman R, Alvarez S, Joubert DW, Matthews SJ. (1979). Drug therapy reviews: methenamine mandelate and methenamine hippurate. Am J Hosp Pharm. (Review of the mechanism of action, pharmacology, safety and clinical efficacy of methenamine for recurrent urinary tract infections mentions that its antimicrobial action depends upon conversion to formaldehyde and ammonia in the bladder and depends upon acidic urine of pH less than 6.5, that hippurate and mandelate reduce urinary pH but also had weak antibacterial activity; adverse events are infrequent, mild and reversible and are largely gastrointestinal intolerance and rash, urticaria or pruritus; no mention of ALT elevations or hepatotoxicity).
Cronberg S, Welin CO, Henriksson L, Hellsten S, Persson KM, Stenberg P. (1987). Prevention of recurrent acute cystitis by methenamine hippurate: double blind controlled crossover long term study. Br Med J (Clin Res Ed). (Among 21 women with recurrent urinary tract infections treated with methenamine or placebo for 2 years, interchanging placebo and therapy every 6 months, 41 infections occurred during placebo therapy but only 11 while on methenamine [2.1 vs 0.8 per patient year]; no discussion of adverse events).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which none were attributed to methenamine).
Lee BS, Bhuta T, Simpson JM, Craig JC. (2012). Methenamine hippurate for preventing urinary tract infections. Cochrane Database Syst Rev. (Systematic review of controlled trials of methenamine hippurate for prevention of urinary tract infections, identified 13 studies with 2037 patients, and identified a suppressive effect of the therapy, and that adverse event rates were low, with uncommon side effects being nausea, diarrhea, bladder pain and rash, but ALT elevations and hepatotoxicity were not mentioned).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to methenamine).
Lo TS, Hammer KD, Zegarra M, Cho WC. (2014). Methenamine: a forgotten drug for preventing recurrent urinary tract infection in a multidrug resistance era. Expert Rev Anti Infect Ther. (Review of methenamine which has been used to treat urinary tract infections for more than 100 years and is available in the US as hippurate or mandelate salts but is currently rarely used, although it has the advantage of excellent tolerability and lack of bacterial resistance; mentions that adverse reactions of nausea, dyspepsia and diarrhea occur in less than 4% of patients, but also that increased ALT and AST levels “have been rarely described and seem reversible upon drug discontinuation”).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to methenamine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to methenamine).
Sihra N, Goodman A, Zakri R, Sahai A, Malde S. (2018). Nonantibiotic prevention and management of recurrent urinary tract infection. Nat Rev Urol. (Extensive review of the evidence for efficacy of non-antibiotic methods for prevention of recurrent urinary tract infections including use of behavioral, dietary, herbal, and probiotic approaches, and d-mannose, NSAIDs, methenamine, estrogens, immunostimulants and vaccines states that methenamine hippurate has been shown to be beneficial and that it “was very well tolerated and the most common adverse events was nausea”).
Barea BM, Veeratterapillay R, Harding C. (2020). Nonantibiotic treatments for urinary cystitis: an update. Curr Opin Urol. (Review of the non-antibiotic approaches to urinary tract infections mentions that therapy with methenamine reduces the risk of recurrence of infections and is safe with a low rate of side effects; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Methenamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Methenamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Methenamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Methenamine)